# Fluoroquinolones

## OVERVIEW

The fluoroquinolones are a family of broad spectrum, systemic antibacterial agents that have been used widely as therapy of respiratory and urinary tract infections. Fluoroquinolones are active against a wide range of aerobic gram-positive and gram-negative organisms. Gram-positive coverage includes penicillinase- and non-penicillinase producing Staphylococci, Streptococcus pneumoniae and viridans, Enterococcus faecalis, Listeria monocytogenes, and Nocardia species. Gram negative coverage includes Neisseria meningitides and gonorrhoeae, Haemophilus influenzae, and most clinically important Enterobacteriaceae species, Pseudomonas aeruginosa and Vibrio species. The fluoroquinolones are believed to act by inhibition of type II DNA topoisomerases (gyrases) that are required for synthesis of bacterial mRNAs (transcription) and DNA replication. They demonstrate little inhibition of human, host enzymes and have had an excellent safety record. The fluoroquinolones are indicated for treatment of several bacterial infections, including bacterial bronchitis, pneumonia, sinusitis, urinary tract infections, septicemia and intraabdominal infections, joint and bone infections, soft tissue and skin infections, typhoid fever, anthrax, bacterial gastroenteritis, urethral and gynecological infections, and pelvic inflammatory disease and several other infectious conditions.

The fluoroquinolones currently available in the United States include ciprofloxacin, gemifloxacin, levofloxacin, moxifloxacin, norfloxacin, and ofloxacin. These agents are well absorbed orally and well tolerated with a low rate of adverse effects. Several quinolones and fluoroquinolones were introduced but were subsequently withdrawn after spontaneous reports of severe adverse events including hepatotoxicity: temafloxacin (1992), gatifloxacin (2006), and trovafloxacin (1999). The currently available fluoroquinolones appear to cause idiosyncratic liver injury rarely, at an estimated rate of 1:100,000 persons exposed. Idiosyncratic liver injury due to fluoroquinolones may be a “class” effect; the pattern of injury is similar, marked by acute and often severe hepatocellular pattern of injury arising within 1 to 4 weeks of starting therapy. The fluoroquinolones most frequently linked to liver injury are ciprofloxacin and levofloxacin, but these two agents also have been most widely used. Minor elevations in liver enzymes occur in 1% to 3% of patients receiving ciprofloxacin, norfloxacin or ofloxacin. Rates with levofloxacin and moxifloxacin are less well defined, but probably similar. The common side effects of the fluoroquinolones are gastrointestinal disturbances, headaches, skin rash and allergic reactions. Less common but more severe side effects include QT prolongation, seizures, hallucinations, tendon rupture, angioedema and photosensitivity.

Ciprofloxacin, delafloxacin, gemifloxacin, levofloxacin, moxifloxacin, norfloxacin, and ofloxacin are discussed separately with individual clinical cases and references. General references and selected publications on fluoroquinolones no longer in use are given below.

- Ciprofloxacin
- Delafloxacin
- Gemifloxacin
- Levofloxacin
- Moxifloxacin
- Norfloxacin
- Ofloxacin

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ciprofloxacin HCl | 86393-32-0 | C17-H18-F-N3-O3.Cl-H.H2-O
Delafloxacin Meglumine | 352458-37-8 | C18-H12-Cl-F3-N4- O4.C7-H17-N-O5
Gemifloxacin | 175463-14-6 | C18-H20-F-N5-O4
Levofloxacin | 100986-85-4 | C18-H20-F-N3-O4
Moxifloxacin HCl | 186826-86-8 | C21-H24-F-N3-O4.Cl-H
Norfloxacin | 70458-96-7 | C16-H18-F-N3-O3
Ofloxacin | 82419-36-1 | C18-H20-F-N3-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2020

Zimmerman HJ. Quinolones. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 603. (Expert review of hepatotoxicity published in 1999; mentions that cinoxacin, nalidixic acid, ciprofloxacin, norfloxacin, enoxacin, and ofloxacin are associated with minor serum enzyme elevations during therapy and with rare instances of clinically apparent liver injury).
Moseley RH. Fluoroquinolones. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 468-9. (Review of hepatotoxicity of fluoroquinolones mentions that hepatocellular and cholestatic forms of injury have been reported due to the quinolones, including cases of ductopenia, acute liver failure and death).
MacDougall C. The quinolones. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1015-8. (Textbook of pharmacology and therapeutics).
Halkin H. (1988). Adverse effects of the fluoroquinolones. Rev Infect Dis. (Combined analysis of databases provided by manufacturers on adverse events of fluoroquinolones in approximately 30,000 persons receiving ciprofloxacin, ofloxacin, pefloxacin, norfloxacin and enoxacin found similar types and rates of adverse events among the agents, overall in 4-8%, elevated liver enzymes in 1.8-2.5%, but eosinophilia in 2.4% with ciprofloxacin and 5-19% with ofloxacin).
Wolfson JS, Hooper DC. (1991). Overview of fluoroquinolone safety. Am J Med. (Review of side effects reported in 22 clinical trials of fluoroquinolones; elevations in ALT and/or Alk P levels occurred in 1.8-2.7% of patients on cipro-, nor-, or ofloxacin).
Blum MD, Graham DJ, McCloskey CA. (1994). Temafloxacin syndrome: review of 95 cases. Clin Infect Dis. (FDA analysis of 95 cases showing hemolysis occurring within 1-2 weeks of starting temafloxacin, most with LDH elevations, half with AST elevations, many with multisystem disease).
Ball P, Tillotson G. (1995). Tolerability of fluoroquinolone antibiotics. Past, present and future. Drug Saf. (Review of the nature and frequency of adverse reactions to the fluoroquinolones mentions that clinically apparent liver injury is rare, but that severe and occasional fatal cases have been reported with ciprofloxacin, levofloxacin, norfloxacin and ofloxacin and from postmarketing surveillance has estimated the frequency of clinically apparent liver injury to be 0.8 per 100,000 recipients).
FDA. http://www.fda.gov/cder/news/trovan/default.htm (FDA advisory concerning trovafloxacin; despite no hepatic adverse event reports during prelicensure studies, spontaneous reports after licensure were common and included 140 cases of hepatotoxicity which led to its withdrawal in 1999).
Bertino J, Fish D. (2000). The safety profile of the fluoroquinolones. Clin Ther. (Systematic review of side effects of fluoroquinolones; common side effects being gastrointestinal intolerance [1-5%], headaches and dizziness [1-2%], and skin rashes [~2%]; trovafloxacin was associated with hepatotoxicity, which was not seen in clinical trials in 7000 patients before approval in 1997, but since then 150 cases of clinically apparent liver toxicity and at least 14 fatalities have been reported).
Chen HJ, Bloch KJ, Maclean JA. (2000). Acute eosinophilic hepatitis from trovafloxacin. N Engl J Med. (66 year old man developed fever and eosinophilia with ALT elevations [841 U/L] without jaundice [bilirubin 1.6 mg/dL] after 4 weeks of trovafloxacin therapy, that rapidly resolved with steroid therapy).
Lucena MI, Andrade RJ, Rodrigo L, Salmeron J, Alvarez A, Lopez-Garrdio MJ, Camargo R, et al. (2000). Trovafloxacin-induced acute hepatitis. Clin Infect Dis. (3 men, ages 33 to 68 years, developed liver injury 7-14 days after starting trovafloxacin [bilirubin 1.2, 5.1 and 29.5 mg/dL, ALT 1990, 716 and 731 U/L, Alk P 1-2.5 times ULN, eosinophils 6-14%], self-limited in all, resolving within 6-8 weeks of stopping).
Henann NE, Zambie MF. (2001). Gatifloxacin-associated acute hepatitis. Pharmacotherapy. (44 year old woman developed jaundice after 5 days of gatifloxacin therapy [bilirubin 4.1 rising to 9.4 mg/dL, ALT 669 U/L, Alk P 243 U/L], resolving within 6 weeks of stopping).
Lazarczyk DA, Goldstein NS, Gordon SC. (2001). Trovafloxacin hepatotoxicity. Dig Dis Sci. (19 year old woman developed rash and fever 5 days after starting trovafloxacin followed one week later by ascites and jaundice [bilirubin 1.3 mg/dL, ALT 901 U/L, Alk P 233 U/L], liver biopsy showing centrolobular necrosis, treated with corticosteroids and recovered).
Rubinstein E. (2001). History of quinolones and their side effects. Chemotherapy. (Between 1985 and 1999, 11 fluoroquinolones in clinical development or already in clinical use were withdrawn because of serious side effects, including trovafloxacin which was implicated in at least 140 cases of clinically apparent liver injury).
Coleman CI, Spencer JV, Chung JO, Reddy P. (2002). Possible gatifloxacin-induced fulminant hepatic failure. Ann Pharmacother. (76 year old man developed jaundice at the end 10 day course of gatifloxacin [bilirubin 5.4 rising to 34.2 mg/dL, ALT 545 U/L, Alk P 110 U/L, INR 1.3 rising to 7], with progressive liver failure and death 25 days later).
Stahlmann R. (2002). Clinical toxicological aspects of fluoroquinolones. Toxicol Lett. (Review of the serious toxicities of the fluoroquinolones, their frequency and possible mechanisms; the hepatotoxicity of trovafloxacin became evident only after approval and approximately 2.5 million prescriptions worldwide, with 140 reported cases of "severe hepatic reactions" despite no serious hepatotoxicity in clinical trials in several thousand patients).
Leone R, Venegoni M, Motola D, Moretti U, Piazzetta V, Cocci A, Resi D, et al. (2003). Adverse drug reactions related to the use of fluoroquinolone antimicrobials: an analysis of spontaneous reports and fluoroquinolone consumption data from three Italian regions. Drug Saf. (Analysis of 432 spontaneous adverse event reports on fluoroquinolones from Italy, 1/3 were serious none of which were liver related).
Cheung O, Chopra K, Yu T, Nalesnik MA, Amin S, Shakil AO. (2004). Gatifloxacin-induced hepatotoxicity and acute pancreatitis. Ann Intern Med. (Two cases of liver injury and mild pancreatitis due to gatifloxacin; 41 year old woman and 19 year old man developed jaundice and abdominal within 1 week of starting therapy [bilirubin 5.1 and 5.5 mg/dL, ALT 145 and 520 U/L, Alk P 482 and 268 U/L], with elevations in amylase and lipase, resolving slowly and incompletely in the first, and rapidly and completely in the second).
Galan MV, Potts JA, Silverman AL, Gordon SC. (2005). The burden of acute nonfulminant drug-induced hepatitis in a United States tertiary referral center. J Clin Gastroenterol. (Ten year experience of 96 patients with acute liver injury, 64 due to viral hepatitis and 32 to drugs; major agents identified being amiodarone, augmentin, minocycline and nitrofurantoin; trovafloxacin accounted for 1 case which was symptomatic but anicteric, resolving within 6 weeks of stopping).
Owens RC, Ambrose PG. (2005). Antimicrobial safety: focus on fluoroquinolones. Clin Infect Dis. (Review of common and rare complications of fluoroquinolones focusing upon QT prolongation, tendon rupture, diabetes, renal injury, and seizures; liver injury discussed in concept of immune related idiosyncratic reactions such as hemolytic anemia, thrombocytopenia, acute interstitial nephritis, Stevens Johnson syndrome, pancreatitis, serum sickness-like syndrome, and eosinophilic meningitis).
Iannini PB. (2007). The safety profile of moxifloxacin and other fluoroquinolones in special patient populations. Curr Med Res Opin. (Review of safety of moxifloxacin and fluoroquinolones in the elderly and patients with liver, kidney, endocrine and cardiovascular disease; no discussion of hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which only 1 was attributed to a fluoroquinolone, ciprofloxacin).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, but no fluoroquinolone was among the top 41 specific causes).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India, none of which were attributed to a fluoroquinolone).
Orman ES, Conjeevaram HS, Vuppalanchi R, Freston JW, Rochon J, Kleiner DE, Hayashi PH, DILIN Research Group. (2011). Clinical and histopathologic features of fluoroquinolone-induced liver injury. Clin Gastroenterol Hepatol. (Among 679 cases of drug induced liver injury presenting between 2004 and 2010 at 8 US medical centers, 12 [1.8%] were attributed to fluoroquinolones including 6 cipro-, 4 moxi-, 1 levo-, and 1 gatifloxacin; average time to onset 4 days [range 1-39], with both hepatocellular and cholestatic enzyme patterns, seven with rash or fever, mortality limited to those with hepatocellular injury and jaundice; hepatic injury appeared to be class specific).
Paterson JM, Mamdani MM, Manno M, Juurlink DN, Canadian Drug Safety and Effectiveness Research Network. (2012). Fluoroquinolone therapy and idiosyncratic acute liver injury: a population-based study. CMAJ. (In a population based study using Canadian health care databases, the risk of admission to hospital for acute liver injury was increased for persons who received a prescription for moxifloxacin or levofloxacin relative to clarithromycin, but not for ciprofloxacin).
Hayashi PH, Chalasani NP. (2012). Liver injury in the elderly due to fluoroquinolones: should these drugs be avoided?. CMAJ. (Editorial in response to Paterson [2013] stressing the low absolute risk of liver injury from the fluoroquinolones [4-9 per 100,000 exposures]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a fluoroquinolone).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 29 [5.1%] attributed to quinolones).
Harr T, French LE. (2012). Stevens-Johnson syndrome and toxic epidermal necrolysis. Chem Immunol Allergy. (Review of the clinical features, epidemiology, genetics and pathogenesis of SJS and TEN).
Naveen KN, Pai VV, Rai V, Athanikar SB. (2013). Retrospective analysis of Steven Johnson syndrome and toxic epidermal necrolysis over a period of 5 years from northern Karnataka, India. Indian J Pharmacol. (Among 22 patients seen at a single referral hospital in India between 2002-2007 with Stevens Johnson syndrome or toxic epidermal necrolysis, 11 were due to anticonvulsants and 7 to antibiotics, including 1 attributed to levofloxacin).
Patel TK, Barvaliya MJ, Sharma D, Tripathi C. (2013). A systematic review of the drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Indian population. Indian J Dermatol Venereol Leprol. (Systematic review of 10 case series of SJS/TEN from India identified 352 cases, among which 342 implicated a medication with most common being antimicrobials [37%], anticonvulsants [16%] and NSAIDs [16%]; fluoroquinolones accounted for 33 cases [10%], 4 of which were due to ciprofloxacin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one due to trovafloxacin [acute liver failure], but none attributed to ciprofloxacin or other fluoroquinolones).
Alshammari TM, Larrat EP, Morrill HJ, Caffrey AR, Quilliam BJ, LaPlante KL. (2014). Risk of hepatotoxicity associated with fluoroquinolones: a national case-control safety study. Am J Health Syst Pharm. (Retrospective analysis of Veterans Affairs patients receiving a fluoroquinolone [n=7862] found a higher relative risk of developing acute liver injury after receipt of ciprofloxacin compared to matched controls [adjusted odds ratio: OR=1.29], but not after receipt of levofloxacin [OR=1.16) or moxifloxacin [OR=0.98]).
Levine C, Trivedi A, Thung SN, Perumalswami PV. (2014). Severe ductopenia and cholestasis from levofloxacin drug-induced liver injury: a case report and review. Semin Liver Dis. (67 year old woman with streptococcal infection developed jaundice 8 weeks after starting levofloxacin [bilirubin 6.3 mg/dL, ALT 614 U/L, Alk P 483 U/L], with prolonged jaundice and biopsy showing bile duct loss).
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. (2014). Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy. (In a nested case control analysis of a health care network database of persons between 2001 and 2009, 8 selected antibiotics were assessed for association with risk of hospitalization for liver injury, adjusted relative risks being significantly elevated for levofloxacin [3.2], moxifloxacin [2.3], doxycycline [2.5], amoxicillin/clavulanate [2.5] and amoxicillin [2.3], but not for clarithromycin [1.8], telithromycin [1.7] or cefuroxime [0.9]).
Goldberg DS, Forde KA, Carbonari DM, Lewis JD, Leidl KB, Reddy KR, Haynes K, et al. Population-representative incidence of drug-induced acute liver failure based on an analysis of an integrated health care system. Gastroenterology 2015; 148: 1353-61. e3. (Analysis of Kaiser Permanente health care database from 2004 to 2011 identified 62 patients with suspected acute liver failure, 32 [52%] of whom had a presumed drug etiology, the most common being acetaminophen [18: 56%] and various herbal products [5: 16%], with single instances attributed to imatinib, simvastatin, leflunomide, isoniazid and valproate, but none to fluoroquinolones).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 38 cases [4%] were attributed to fluoroquinolones, including 16 due to ciprofloxacin [the 8th most common prescription drug cause], 13 due to levofloxacin and 8 to moxifloxacin).
Xu P, Chen H, Xu J, Wu M, Zhu X, Wang F, Chen S, Xu J. (2017). Moxifloxacin is an effective and safe candidate agent for tuberculosis treatment: a meta-analysis. Int J Infect Dis. (Metaanalysis of nine controlled studies of the addition of moxifloxacin to antituberculosis drug regimens concludes that addition of moxifloxacin may increase the rate of culture conversion and decrease the rate of relapse but does not increase the rate of adverse events; no specific mention or discussion of rates of ALT elevations or hepatotoxicity).
Marin AC, Nyssen OP, McNicholl AG, Gisbert JP. (2017). Efficacy and safety of quinolone-containing rescue therapies after the failure of non-bismuth quadruple treatments for Helicobacter pylori eradication: systematic review and meta-analysis. Drugs. (Systematic review of efficacy of fluoroquinolone-containing therapies of H. pylori infection after failure of standard treatments found eradication in 80% with triple and 90% with quadruple therapy; rates of specific adverse events were not discussed).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, Ghabril MS, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss of whom 94% developed evidence of chronic liver injury suggestive of vanishing bile duct syndrome, 2 of which were due to fluoroquinolones, 1 to moxifloxacin and 1 levofloxacin).
Markham A. (2017). Delafloxacin: first global approval. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of delafloxacin; mentions that aminotransferase elevations occur in 3-4% of treated patients, but cases of clinically apparent liver injury with jaundice were not observed in the prelicensure studies).
Yim HJ, Suh SJ, Jung YK, Yim SY, Seo YS, Lee YR, Park SY, Jang JY, Kim YS, Kim HS, Kim BI, Um SH. (2018). Daily norfloxacin vs. weekly ciprofloxacin to prevent spontaneous bacterial peritonitis: a randomized controlled trial. Am J Gastroenterol. (Among 124 patients with cirrhosis and ascites given prophylaxis with daily norfloxacin [400 mg] or weekly oral ciprofloxacin [750 mg], subsequent rates of bacterial peritonitis were similar [7% vs 5%] as were rates of liver transplantation and death).
Moreau R, Elkrief L, Bureau C, Perarnau JM, Thévenot T, Saliba F, Louvet A, et al., NORFLOCIR Trial Investigators. (2018). Effects of long-term norfloxacin therapy in patients with advanced cirrhosis. Gastroenterology. (Among 291 patients with advanced cirrhosis treated for 6-12 months with daily oral norfloxacin or placebo, 6-month mortality rate was less with norfloxacin [15% vs 19%] as were gram-negative bacterial infections and no norfloxacin related severe adverse events were identified).
Dixit A, Karandikar MV, Jones S, Nakamura MM. (2018). Safety and tolerability of moxifloxacin in children. J Pediatric Infect Dis Soc. (Among 221 children who received 300 course of moxifloxacin, drug related aminotransferase elevations occurred in 8 [2.7%], with ALT ranging from 114-805 U/L and AST from 96-807 U/L]; no mention of jaundice or need for discontinuation).
Tweed CD, Wills GH, Crook AM, Dawson R, Diacon AH, Louw CE, McHugh TD, et al. (2018). Liver toxicity associated with tuberculosis chemotherapy in the REMoxTB study. BMC Med. (Analysis of liver test abnormalities occurring in a trial of 1928 patients comparing standard 6 month isoniazid based regimens with shorter 4 month regimens using moxifloxacin and ethambutol found ALT elevations above 3 times ULN in 5.2% overall, 9.4% with standard therapy, 8% with 4 month course and 6% with 4 month course using ethambutol instead of isoniazid; two patients died of liver failure, one with rash, hemodynamic instability and rising bilirubin that was considered “hepatitis of unknown cause”).
(2018). Comparison table: some systemic fluoroquinolones. Med Lett Drugs Ther. (Table comparing 4 fluoroquinolones [cipro-, levo-, dela- and moxifloxacin] mentions that ALT and AST elevations are a class adverse event).
(2018). Delafloxacin (Baxdela)--a new fluoroquinolone antibiotic. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of delafloxacin shortly after its approval for use in the US; mentions adverse side effects of aminotransferase elevations [3%] and that it, like other fluoroquinolones, has a boxed warning about tendinitis, tendon rupture, peripheral neuropathy and CNS effects, and that it can also lead to C. difficile diarrhea).
Mavros MN, Theochari NA, Kyriakidou M, Economopoulos KP, Sava JA, Falagas ME. (2019). Fluoroquinolone-based versus β-lactam-based regimens for complicated intra-abdominal infections: a meta-analysis of randomised controlled trials. Int J Antimicrob Agents. (Systematic review of controlled trials of fluoroquinolones versus β-lactam based antibiotic regimens found similar rates of efficacy and adverse events; no discussion of ALT elevations or liver related toxicities).
Kuula LSM, Viljemaa KM, Backman JT, Blom M. (2019). Fluoroquinolone-related adverse events resulting in health service use and costs: A systematic review. PLoS One. (Systematic review of observational studies on safety of fluoroquinolones concluded that due to lack of published literature, health service and costs could not be evaluated).

## OTHER REFERENCE LINKS

1 Recent References on Fluoroquinolones: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=fluoroquinolones/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/01/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fluoroquinolones: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluoroquinolones)